# Ethambutol

## OVERVIEW

### Introduction

Ethambutol is a first line but adjunctive antituberculosis medication which is used only in combination with other agents such as isoniazid and rifampin. Ethambutol therapy has been associated with minor, transient and asymptomatic elevations in serum aminotransferase levels, and is a reported but rare cause of clinically apparent acute liver injury.

### Background

Ethambutol (eth am' bue tol) is a semisynthetic antibiotic which is bacteriostatic against Mycobacterium tuberculosis. Ethambutol interferes with the incorporation of mycolic acid into the mycobacterial cell wall, thus inhibiting its cell wall synthesis. Ethambutol has a broader spectrum of activity against mycobacterial species than isoniazid or rifampin and is therefore used largely in patients with suspected resistance or in atypical mycobacterial infections. Ethambutol is available in generic forms in tablets of 100 and 400 mg. The recommended dose is 15 mg/kg once daily in combination with other antituberculosis medications such as isoniazid, rifampin, pyrazinamide, and streptomycin. Higher doses are recommended for patients being retreated after a relapse. It is most typically given with pyrazinamide for the first two months of combination therapy of suspected resistant tuberculosis with isoniazid and rifampin, the latter two continuing for at least six months. Common side effects include gastrointestinal upset, nausea, dizziness, fever, and rash.

The management of drug-resistant tuberculosis is challenging and should be under the direction of physicians with expertise in tuberculosis therapy and management of its side effects. Optimal regimens of therapy for tuberculosis are complex and change frequently. Regularly updated recommendations on use of drugs for tuberculosis, including indications, contraindications, warnings, dosages and monitoring recommendations are available at the Centers for Disease Control and Prevention website: https://www.cdc.gov/tb/publications/guidelines/Treatment.htm.

### Hepatotoxicity

Because ethambutol is almost always used in combination with isoniazid, rifampin or other antituberculosis agents, the frequency of serum aminotransferase elevations attributable to ethambutol alone cannot be estimated with any confidence. The addition of ethambutol to isoniazid, rifampin or pyrazinamide does not appear to increase the rate of transient ALT elevations during therapy. In addition, ethambutol is a rare cause of acute, symptomatic liver injury. Despite 50 years of use, ethambutol has been linked to clinically apparent liver injury in only a few case reports. In the best described instance (Case 1), the onset of symptoms was 2 months after starting combination antituberculosis therapy and, in contrast to liver injury due to isoniazid or pyrazinamide, the pattern of serum enzymes was distinctly cholestatic. The recurrence of liver injury upon rechallenge with ethambutol but not isoniazid made the attribution convincing. Other case reports have described liver injury occurring in the context of DRESS syndrome, arising within 2 to 6 weeks of starting antituberculosis therapy with fever, rash, eosinophilia and other organ involvement such as liver, kidney and lung. Several published instances have described recurrence of injury after rechallenge with ethambutol.

Likelihood score: C (probable cause of clinically apparent liver injury often in the context of DRESS syndrome).

### Mechanism of Injury

The cause of liver injury due to ethambutol is not known, but is likely due to hypersensitivity.

### Outcome and Management

Ethambutol is one of the few antituberculosis medications that is generally safe in the setting of liver disease. In the unlikely event of clinically apparent liver injury or allergic reaction to ethambutol, rechallenge, if necessary, should be done with caution. There does not appear to be cross sensitivity to liver injury with other antituberculosis medications.

[First line medications used in the therapy of tuberculosis in the US include ethambutol, isoniazid, pyrazinamide, rifabutin, rifampin, and rifapentine. Second line medications include streptomycin, capreomycin, cycloserine, ethionamide, bedaquiline, pretomanid, fluoroquinolones such as levofloxacin and moxifloxacin, aminoglycosides such as amikacin, and para-aminosalicylic acid (PAS).]

Drug Class: Antituberculosis Agents

Other Drugs in the Class: Bedaquiline, Capreomycin, Cycloserine, Ethionamide, Isoniazid, Pretomanid, Pyrazinamide, Rifabutin, Rifampin, Rifapentine, Streptomycin

## CASE REPORT

### Case 1. Cholestatic hepatitis caused by ethambutol.(1)

A 76 year old woman with pulmonary tuberculosis developed jaundice without abdominal pain or nausea two months after starting a course of isoniazid, streptomycin and ethambutol. She had no history of liver disease or excessive alcohol use. Liver tests were reported to be normal before starting therapy. Laboratory results showed a total serum bilirubin of 11.8 mg/dL with marked elevations in alkaline phosphatase [976 U/L] and gamma glutamyl transpeptidase [616 U/L] (Table). Tests for hepatitis A and B and for autoantibodies were negative. Ultrasound examination of the abdomen showed no evidence of biliary obstruction, and a liver biopsy showed intrahepatic cholestasis. On first presentation with jaundice, all medications were stopped and she began to improve. The initial diagnosis was isoniazid induced liver injury. Accordingly, therapy was reinstituted using ethambutol alone. Within 6 days, serum AST and alkaline phosphatase levels increased (Table). Ethambutol was stopped for 11 days and again restarted; however, serum alkaline phosphatase levels again rose, and ethambutol was permanently discontinued. After further improvements, isoniazid and streptomycin were restarted and subsequent treatment was well tolerated without recurrence of evidence of liver injury.

#### Key Points

Medication: | Ethambutol (750 mg daily)
Pattern: | Cholestatic (R=0.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 months
Recovery: | Interrupted by rechallenge, ultimately complete
Other medications: | Isoniazid, streptomycin

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin (mg/dL) | Other
8 weeks | 0 | 264 | 976 | 11.8 | Therapy stopped
9 weeks | 1 week | 144 | 767
Ethambutol restarted for 6 days
10 weeks | 0 | 356 | 1225
| 2 days | 280 | 1050
| 4 days | 300 | 1020
11 weeks | 7 days | 260 | 950
| 10 days | 76 | 812
Ethambutol restarted for 4 days
12 weeks | 0 | 228 | 1128
| 3 days | 120 | 1020
| 6 days | 110 | 1000
13 weeks | 10 days | 105 | 700
Normal Values | | <40 | <130 | <1.2

* Some values estimated from Figure 1.

#### Comment

The role of ethambutol was defined by the response to rechallenge on two occasions during recovery and the later tolerance of isoniazid without worsening of blood test results. Also suggestive was the cholestatic pattern which is rare with isoniazid as well as the lack of viral hepatitis-like symptoms of nausea, abdominal pain and fatigue. Cholestatic hepatitis is marked by slow improvements in liver tests. The laboratory results were said to have “…slowly returned to normal…” but were not provided.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ethambutol – Generic, Myambutol®

DRUG CLASS

Antituberculosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ethambutol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ethambutol | 74-55-5 | C10-H24-N2-O2

## CITED REFERENCES

1 Gulliford M, Mackay AD, Prowse K. (1986). Cholestatic jaundice caused by ethambutol. Br Med J (Clin Res Ed).

## ANNOTATED BIBLIOGRAPHY

References updated: 24 December 2020

Abbreviations: HIV, human immunodeficiency virus; DRESS, drug rash with eosinophilia and systemic symptoms; MAC, Mycobacterium avium complex; PAS, para-aminosalicylic acid.

Zimmerman HJ. Antituberculosis agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 611-21. (Extensive review of hepatotoxicity of antituberculosis medications including ethambutol published in 1999; mentions a single case report of hepatotoxicity).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs).
Gumbo T. Chemotherapy of tuberculosis, mycobacterium avium complex disease and leprosy. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1067-86. (Textbook of pharmacology and therapeutics).
Lederman RJ, Davis FB, Davis PJ. (1968). Exchange transfusion as treatment of acute hepatic failure due to antituberculosis drugs. Ann Intern Med. (23 year old woman developed acute fever, rash and malaise 41 days after starting isoniazid, ethambutol and PAS for tuberculosis [bilirubin 3.0 rising to 30 mg/dL, ALT 850, Alk P 2 times ULN], accompanied by confusion and coma; treated with exchange transfusions and recovered; PAS was stopped promptly, but isoniazid continued for a period).
Hellström PE, Repo UK. (1969). Capreomycin, ethambutol and rifampicin in apparently incurable pulmonary tuberculosis. Scand J Respir Dis Suppl. (Retrospective analysis of 35 patients with severe, chronic or relapsing tuberculosis who were treated with capreomycin, ethambutol and rifampin; “liver damage” occurred in 49%, but was reversible in all; details not given).
Repo UK, Hellström PE. (1970). Capreomycin and ethambutol in pulmonary tuberculosis. A preliminary report. Scand J Respir Dis Suppl. (Retrospective analysis of 29 patients with severe tuberculosis treated with capreomycin and ethambutol with a third agent; “liver damage” occurred in 10%, but was reversible in all and consisted of mild elevations in ALT, AST and BSP retention).
Lees AW, Allan GW, Smith J, Tyrrell WF, Fallon RJ. (1971). Toxicity from rifampicin plus isoniazid and rifampicin plus ethambutol therapy. Tubercle. (Among 105 patients with active tuberculosis treated with isoniazid and rifampin, 22% had ALT and 13% bilirubin elevations, 8% skin rash and 3 a hypersensitivity reaction, two with jaundice [bilirubin 3.8 and 1.8 mg/dL; ALT 330 and 235 U/L], resolving on stopping).
Zierski M. (1973). A trial of intermittent rifampin and ethambutol in retreatment regimens. Scand J Respir Dis Suppl. (122 patients with tuberculosis were treated with rifampin and ethambutol daily for 2 months and then once or twice weekly for 1-2 years; abnormal liver tests occurred in 10% during daily regimen, 5% during long term treatment, but all changes were transient and mild not requiring discontinuation and attributed to rifampin).
Austerhoff A, Kindler U, Knop P, Knieriem HJ. (1974). Dtsch Med Wochenschr.
Năstase M, Năstase R, Brener E. (1975). Rev Ig Bacteriol Virusol Parazitol Epidemiol Pneumoftiziol Pneumoftiziol.
Rossouw JE, Saunders SJ. (1975). Hepatic complications of antituberculous therapy. Q J Med. (Retrospective review identified 38 cases of hepatitis [~0.32%] due to antituberculosis therapy [Capetown, SA] 16 due to PAS, 12 to PAS with isoniazid, 3 isoniazid alone, 1 each of others including ethambutol; details of case attributed to ethambutol were not provided).
Casteels-Van Daele M, Igodt-Ameye L, Corbeel L, Eeckels R. (1975). Hepatotoxicity of rifampicin and isoniazid in children. J Pediatr. (13 year old boy developed symptoms 7 days and coma 11 days after starting isoniazid, rifampin and ethambutol for active tuberculosis [bilirubin 5.2 mg/dL, ALT 1500, Alk P 302, prothrombin index <10%], but recovering spontaneously and later treated with isoniazid without recurrence).
Girling DJ. (1978). The hepatic toxicity of antituberculosis regimens containing isoniazid, rifampicin and pyrazinamide. Tubercle. (History and review of hepatotoxicity of first line antituberculosis medications).
Chapoy P, Ferracci JP, Mattei JF, Granjon B, Louchet E. (1978). Pediatrie. (Two children, ages 4 and 12 years with onset of severe hepatitis 3 and 8 months after starting rifampin, isoniazid and PAS/prothionamide; one case was fatal and one resulted in cirrhosis; authors attributed injury to isoniazid).
Addington WW. (1979). The side effects and interactions of antituberculosis drugs. Chest. (Review of side effects of antituberculosis medications states that isoniazid, rifampin and pyrazinamide are major causes of hepatotoxicity, whereas ethambutol rarely causes liver injury).
Zierski M, Bek E. (1980). Side-effects of drug regimens used in short-course chemotherapy for pulmonary tuberculosis. A controlled clinical study. Tubercle. (Among 530 patients treated with 5 regimens [which included isoniazid, rifampin, streptomycin, pyrazinamide and ethambutol] for active tuberculosis and monitored monthly, 9% developed hepatic injury but usually without symptoms, ALT >250 U/L in 6 [1.1%], bilirubin rise in 7 [1.3%]).
Bobrowitz ID. (1980). Ethambutol compared to rifampin in original treatment of pulmonary tuberculosis. Lung. (218 patients treated with 3 regimens for tuberculosis; isoniazid with rifampin or ethambutol or both for 4 months followed by isoniazid for 20 months; 39 [18%] developed abnormal liver tests; 5 cases of hepatitis attributed to rifampin [2-8 weeks: overall 3.4%] and 3 to isoniazid [1-16 months: 1.3%], none to ethambutol).
Snider D, Long M, Zierski M, Rogowski J, Bek E. (1981). Preliminary results of six-month regimens studied in the United States and in Poland. Chest. (Comparison of efficacy of 6-month vs 15-month regimens [the latter including ethambutol] for active tuberculosis in 672 patients, 9 relapses after short but none after long duration regimen; 21 [3.1%] had hepatotoxicity).
Døssing M, Andreasen PB. (1982). Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol. (Among 572 reports of drug induced liver injury from Denmark between 1968 and 1978, the most common causes were halothane [25%], chlorpromazine [9%], sulfonamides [9%], antituberculosis agents [7%], oxyphenisatin[4%], and methyldopa [2%]).
Fiala W, Häcki MA, Brändli O. (1983). Schweiz Med Wochenschr. (Controlled trial comparing pyrazinamide [n=52: <2 g/day] vs ethambutol [n=61] for first 2-3 months with isoniazid and rifampin for 9 months to treat active tuberculosis; hepatitis occurred in 5 on pyrazinamide and 2 on ethambutol, all in first month, 3 symptomatic, no deaths, most were >70 years of age).
Cohen CD, Sayed AR, Kirsch RE. (1983). Hepatic complications of antituberculosis therapy revisited. S Afr Med J. (Among 5565 patients treated for tuberculosis in Capetown SA, 17 [0.3%] developed hepatitis, rate similar to that when PAS was used. Among 28 cases seen, 13 attributed to isoniazid, 16 pyrazinamide and 8 rifampin, mostly in combination; 2 deaths).
Homberg JC, Abuaf N, Helmy-Khalil S, Biour M, Poupon R, Islam S, Darnis F, et al. (1985). Drug-induced hepatitis associated with anticytoplasmic organelle autoantibodies. Hepatology. (Analysis of autoantibodies in 157 cases of drug induced liver injury; 3 categories–drugs that are associated with and without antibodies to cytoplasmic organelles and those with specific antibodies; 4 cases of isoniazid hepatitis had no antibodies to nuclei, mitochondria, liver microsomes or smooth muscle).
Gulliford M, Mackay AD, Prowse K. (1986). Cholestatic jaundice caused by ethambutol. Br Med J (Clin Res Ed). (78 year old woman developed jaundice 2 months after starting isoniazid, streptomycin and ethambutol [bilirubin 11.8 mg/dL, AST 264 U/L, Alk P 976 U/L] with negative rechallenge to isoniazid and positive rechallenge twice to ethambutol [Alk P rising from 767 to 1225 U/L, AST from 144 to 356 U/L], later tolerating isoniazid and streptomycin long term: Case 1).
van Aalderen WMC, Knoester H, Knol K. (1987). Fulminant hepatitis during treatment with rifampicin, pyrazinamide and ethambutol. Eur J Pediatr. (10 year old girl developed nausea and ALT elevations 2 weeks after starting isoniazid, rifampin, pyrazinamide and ethambutol resolving with stopping all drugs, but severe recurrence with fever, rash and fatal acute liver failure 6 weeks after adding pyrazinamide back to rifampin, ethambutol and kanamycin).
Donald PR, Schoeman JF, O’Kennedy A. (1987). Hepatic toxicity during chemotherapy for severe tuberculosis meningitis. Am J Dis Child. (Among 33 children with tuberculous meningitis treated with 3-4 agents, liver test abnormalities were common [85%], but usually mild and transient, only one child developing jaundice who was also IgM anti-HAV positive and who later tolerated therapy without recurrence).
Kasantikul V. (1989). Isoniazid-rifampicin-induced submassive hepatic necrosis. J Med Assoc Thai. (58 year old woman developed nausea 3 weeks after starting isoniazid, rifampin and ethambutol and jaundice 3 weeks later [bilirubin 3.7 mg/dL, ALT 1590 U/L, Alk P 54 U/L, protime 72 sec], dying 5 days later).
Wu JC, Lee SD, Yeh PF, Chan CY, Wang YJ, Huang YS, Tsai YT, et al. (1990). Isoniazid-rifampin-induced hepatitis in hepatitis B carriers. Gastroenterology. (Among 1783 patients with active tuberculosis treated with combination therapy [isoniazid, rifampin and ethambutol], 42 [2.3%] developed clinical hepatitis of whom 15 were HBsAg positive, fatality rate being 47% vs 4%, but no information on background features in the treated cohort or exclusion of reactivation of hepatitis B).
Taneja DP, Kaur D. (1990). Study on hepatotoxicity and other side-effects of antituberculosis drugs. J Indian Med Assoc.
Chiu J, Nussbaum J, Bozzette S, Tilles JG, Young LS, Leedom J, Heseltine PN, et al., California Collaborative Treatment Group. (1990). Treatment of disseminated Mycobacterium avium complex infection in AIDS with amikacin, ethambutol, rifampin, and ciprofloxacin. Ann Intern Med. (17 patients with AIDs and mycobacterium avium complex infection were treated with amikacin for 4 weeks and then 12 weeks of ciprofloxacin, ethambutol and rifampin; therapy stopped early in 2 patients for hepatitis, but no details given).
Aziz S, Agha F, Hassan R, Fairoz SA, Hassan K. (1990). Hepatotoxicity to different antituberculosis drug combinations. J Pak Med Assoc.
Altman C, Biour M, Grangé JD. (1993). Presse Med. (Analysis of 199 cases of hepatotoxicity from antituberculosis medications from literature [n=169] and French pharmacovigilance system [n=30]; overall mortality rate was 23%, rifampin cases had short latency [average 2 weeks] compared to isoniazid [11 weeks] and pyrazinamide [7 weeks]; one case attributed to ethambutol in the literature, none in their own series).
Türktaş H, Unsal M, Tülek N, Orüç O. (1994). Hepatotoxicity of antituberculosis therapy (rifampicin, isoniazid and pyrazinamide) or viral hepatitis. Tuber Lung Dis. (Among 705 Turkish adults with tuberculosis, 57 [8%] developed hepatitis with jaundice during therapy with isoniazid and rifampin; serologic testing showed hepatitis A in none, B in 6 and C in 4).
Singh J, Arora A, Garg PK, Thakur VS, Pande JN, Tandon RK. (1995). Antituberculosis treatment-induced hepatotoxicity: role of predictive factors. Postgrad Med J. (Case control study of 60 patients with liver injury due to antituberculosis medications and 60 controls from India identified lower BMI and pyrazinamide, but not age, sex, or acetylator status as risk factors).
Singh J, Garg PK, Tandon RK. (1996). Hepatotoxicity due to antituberculosis therapy. Clinical profile and reintroduction of therapy. J Clin Gastroenterol. (Among 72 patients with symptomatic liver injury due to antituberculosis medications, 12 had acute or subacute liver failure; among those who recovered, reinstitution of therapy was possible in 93%).
Ormerod LP, Horsfield N. (1996). Frequency and type of reactions to antituberculosis drugs: observations in routine treatment. Tuber Lung Dis. (Among 1317 patients treated for active tuberculosis, hepatitis was attributed to rifampin in 1.4%, pyrazinamide in 1.2% and isoniazid in 0.3%, but none to ethambutol or streptomycin).
Ormerod LP, Skinner C, Wales J. (1996). Hepatotoxicity of antituberculosis drugs. Thorax. (Review of hepatotoxicity of antituberculosis medications and recommendations on monitoring, with biochemical monitoring recommended only for patients with preexisting liver disease; in the UK between 1965-86, there were 243 reports of liver injury due to antituberculosis therapy and 45 fatalities).
Pande JN, Singh SP, Khilnani GC, Khilnani S, Tandom RK. (1996). Risk factors for hepatotoxicity from antituberculosis drugs: a case-control study. Thorax. (Comparison of 86 patients with hepatitis due to antituberculosis therapy with 406 patients who tolerated therapy; risk factors were older age, history of high alcohol intake [20% vs 5%], more extensive disease [14% vs 3.5%], slow acetylator status [83% vs 64%] and use of pyrazinamide [63% vs 25%]).
Døssing M, Wilcke JT, Askgaard DS, Nybo B. (1996). Liver injury during antituberculosis treatment: an 11-year study. Tuber Lung Dis. (Retrospective chart review on 765 Danish patients treated for tuberculosis with 3 or 4 drugs for 6-9 months; 16% had AST elevations >2 times ULN usually in first month, but only 2% required modification of the regimen; 7 with jaundice, no fatalities; risk factors for hepatotoxicity were female sex, age and severe tuberculosis).
Durand F, Jebrak G, Pessayre D, Fournier M, Bernuau J. (1996). Hepatotoxicity of antitubercular treatments. Rationale for monitoring liver status. Drug Saf. (Review and recommendations from France regarding monitoring of serum enzymes during therapy of tuberculosis; isoniazid may have direct hepatotoxicity because of dose relatedness and usual absence of recurrence on rechallenge; rifampin is rare cause of liver injury, usually with short latency period; pyrazinamide is clearly hepatotoxic at higher doses which should be kept to a minimum and for only 2 months).
García Rodríguez LA, Ruigómez A, Jick H. (1997). A review of epidemiologic research on drug-induced acute liver injury using the general practice research data base in the United Kingdom. Pharmacotherapy. (In epidemiological studies, antituberculosis medications have the highest relative risk for liver injury, hepatitis occurring in 0.4% of recipients).
Tahaoğlu K, Ataç G, Sevim T, Tärün T, Yazicioğlu O, Horzum G, Gemci I, et al. (2001). The management of anti-tuberculosis drug-induced hepatotoxicity. Int J Tuberc Lung Dis. (Description of 45 patients with hepatotoxicity from antituberculosis therapy, ages 15-76 years, ALT 42-897 U/L, bilirubin 0.2-7.0 mg/dL, arising in 6-102 days, with resolution in 4-58 days. No recurrence in those with gradual reintroduction of regimen without pyrazinamide compared to 6 cases [24%] in those with abrupt reintroduction).
Ohkawa K, Hashiguchi M, Ohno K, Kiuchi C, Takahashi S, Kondo S, Echizen H, et al. (2002). Risk factors for antituberculous chemotherapy-induced hepatotoxicity in Japanese pediatric patients. Clin Pharmacol Ther. (Retrospective analysis of 99 children who received therapy for tuberculosis, 8 developed hepatotoxicity; risk factors identified were young age and pyrazinamide exposure).
Hussain Z, Kar P, Husain SA. (2003). Antituberculosis drug-induced hepatitis: risk factors, prevention and management. Indian J Exp Biol. (Review article on role of genetic polymorphisms of NAT2, CYP 2E1 and glutathione-S-transferase in hepatotoxicity of antituberculosis therapies).
el-Agroudy AE, Refaie AF, Moussa OM, Ghoneim MA. (2003). Tuberculosis in Egyptian kidney transplant recipients: study of clinical course and outcome. J Nephrol. (Among 1200 kidney transplant recipients, 45 [4%] developed tuberculosis usually after several years, all treated with isoniazid, rifampin and ethambutol; hepatotoxicity in 11 [25%], but severe in only 3).
Kurokawa I, Nakahigashi Y, Teramachi M. (2003). Erythema multiforme-type drug eruption due to ethambutol with eosinophilia and liver dysfunction. Int J Antimicrob Agents. (42 year old woman developed erythema multiforme 10 weeks after starting isoniazid, rifampin, pyrazinamide and ethambutol for pulmonary tuberculosis with 34% eosinophils, ALT 312 U/L and normal bilirubin resolving in 2 weeks on prednisone, positive rechallenge to ethambutol with rash; tolerated other agents).
Yee D, Valiquette C, Pelletier M, Parisien I, Rocher I, Menzies D. (2003). Incidence of serious side effects from first-line antituberculosis drugs among patients treated for active tuberculosis. Am J Respir Crit Care Med. (Among 408 adult patients treated for tuberculosis, 37 [9%] had 46 serious adverse events including 12 instances of hepatitis [3%: 11 symptomatic, ALT >5 times ULN]; risk factors were age [hazard ratio 4.8-7.7], female sex [2.2] and Asian birthplace [2.2]; hepatitis arose in 2% on pyrazinamide and 1% on isoniazid).
Fernández-Villar A, Sopeña B, Fernández-Villar J, Vázquez-Gallardo R, Ulloa F, Leiro V, Mosteiro M, et al. (2004). The influence of risk factors on the severity of anti-tuberculosis drug-induced hepatotoxicity. Int J Tuberc Lung Dis. (Among 471 patients receiving antituberculosis therapy, 56 [12%] developed ALT elevations above 3 times ULN, 16 [3.4%] and symptoms and 5 [1%] were jaundiced; no deaths. Rates of hepatotoxicity higher in patients with risk factors than without [18.2% vs 5.6%]).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 124 for acetaminophen and 137 for other toxins, the most common being isoniazid [24], propylthiouracil [13], phenytoin [10], valproate [10], amanita [9], nitrofurantoin [7], herbals [7], ketoconazole [6], disulfiram [6], troglitazone [4] and 28 others).
Marra F, Cox VC, FitzGerald JM, Moadebi S, Elwood RK. (2004). Successful treatment of multidrug-resistant tuberculosis following drug-induced hepatic necrosis requiring liver transplant. Int J Tuberc Lung Dis. (28 year old woman with tuberculous lymphadenitis treated with isoniazid, rifampin, ethambutol and pyrazinamide, switching to ciprofloxacin with pyrazinamide and ethambutol when resistance testing was done; four days later she developed fever, rash and fatigue [bilirubin normal, ALT 285 U/L, Alk P normal], but then worsened [bilirubin 15.2 mg/dL, ALT 1165 U/L, Alk P 141 U/L] and ultimately required liver transplant, yet later was treated successfully with levofloxacin, amikacin and streptomycin).
Younossian AB, Rochat T, Ketterer JP, Wacker J, Janssens JP. (2005). High hepatotoxicity of pyrazinamide and ethambutol for treatment of latent tuberculosis. Eur Respir J. (Among 12 persons treated with pyrazinamide and ethambutol for latent tuberculosis and contact with a patient with multidrug resistant disease, 7 developed liver injury [ALT 82-1338 U/L], after 87 to 247 days, 3 with symptoms, no mention of bilirubin levels).
Andrade RJ, Lucena MI, Fernandez MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology. (Among 446 cases of drug induced liver injury collected in Spain between 1984-2004, isoniazid [with or without rifampin and pyrazinamide] was implicated in 22 cases [5%: ranking 3rd] and was fatal or required liver transplant in 5 [ranking first]).
Lee BH, Koh WJ, Choi MS, Suh GY, Chung MP, Kim H, Kwon OJ. (2005). Inactive hepatitis B surface antigen carrier state and hepatotoxicity during antituberculosis chemotherapy. Chest. (Retrospective case control study of 110 HBsAg carriers and 97 controls from Korea who received 3-4 drug antituberculosis therapy; any ALT elevations occurred in 34% of carriers vs 20% of controls and were >3 times ULN in 8% vs 4%; no risk factors identified, most tolerated reintroduction of therapy without pyrazinamide).
Yew WW, Leung CC. (2006). Antituberculosis drugs and hepatotoxicity. Respirology. (Review of incidence, causes, risk factors and management of hepatotoxicity of antituberculosis medications).
Saukkonen JJ, Cohn DL, Jasmer RM, Schenker S, Jereb JA, Nolan CM, Peloquin CA, et al. (2006). ATS (American Thoracic Society) Hepatotoxicity of Antituberculosis Therapy Subcommittee. An official ATS statement: hepatotoxicity of antituberculosis therapy. Am J Respir Crit Care Med. (American Thoracic Society recommendations regarding hepatotoxicity of antituberculosis therapy; for latent infection, 9 months of isoniazid is first choice and 4 months of rifampin second; clinical monitoring is recommend for all patients and biochemical monitoring for those at high risk and possibly the elderly [ALT values at 1, 3 and 6 months or every 1-2 months]; hold therapy if ALT above 5 times ULN or if symptoms are present and ALT is above 3 times ULN; mentions that there has been only one report of ethambutol hepatoxicity).
Forget EJ, Menzies D. (2006). Adverse reactions to first-line antituberculosis drugs. Expert Opin Drug Saf. (Review of side effects including hepatotoxicity of isoniazid, asymptomatic elevations in ALT levels occur in 10-22% of patients, but 80% of these resolve even with continuing therapy; overall rate of hepatotoxicity is 0.9%, mortality 0.04%).
Shigeto E, Committee for Treatment Japanese Society for Tuberculosis. (2007). Kekkaku. (Abstract: Survey questionnaire to 114 Japanese hospitals identified 70 cases of severe liver injury and 8 deaths due to antituberculosis therapy between 1994-2003).
Idilman R, Ersoz S, Coban S, Kumbasar O, Bozkaya H. (2006). Antituberculous therapy-induced fulminant hepatic failure: successful treatment with liver transplantation and nonstandard antituberculous therapy. Liver Transpl. (19 year old woman with peritoneal tuberculosis developed jaundice 4 days after starting isoniazid, rifampin, ethambutol and pyrazinamide [bilirubin 10.5 mg/dL, ALT 1332 U/L, protime 71 sec], undergoing living donor liver transplantation within 2 days and afterwards treated with streptomycin, ethambutol and cycloserine with no recurrence).
Björnsson E, Kalaitzakis E, Olsson R. (2007). The impact of eosinophilia and hepatic necrosis on prognosis in patients with drug-induced liver injury. Aliment Pharmacol Ther. (Review of 570 case reports of drug induced liver injury suggested that eosinophilia was associated with a favorable prognosis, lower peak bilirubin and lower fatality rate).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain calculated relative risk of injury compared to the general population to be 1300 with use of triple therapy [isoniazid, rifampin and pyrazinamide] and 154 for isoniazid alone, ranking first and third).
Kwon YS, Koh WJ, Suh GY, Chung MP, Kim H, Kwon OJ. (2007). Hepatitis C virus infection and hepatotoxicity during antituberculosis chemotherapy. Chest. (Retrospective analysis of 54 patients with HCV infection and 97 controls receiving therapy for active tuberculosis; ALT >3 times ULN occurred in 13% of HCV infected vs 4% of controls; none died or required hospitalization).
Aouam K, Chaabane A, Loussaïef C, Ben Romdhane F, Boughattas NA, Chakroun M. (2007). Med Mal Infect. (Review of toxicities of antituberculosis agents; ethambutol can cause optic neuritis, allergic reactions, and rash; liver injury is rare except for mild hyperbilirubinemia not requiring dose adjustment).
Huang YS. (2007). Genetic polymorphisms of drug-metabolizing enzymes and the susceptibility to antituberculosis drug-induced liver injury. Expert Opin Drug Metab Toxicol. (Two gene variants have been linked to an increased risk of hepatotoxicity of antituberculosis medications; NAT2 and CYP 2E1, but the associations require further confirmation).
Marzuki OA, Fauzi AR, Ayoub S, Kamarul Imran M. (2008). Prevalence and risk factors of anti-tuberculosis drug-induced hepatitis in Malaysia. Singapore Med J. (Among 473 patients treated for tuberculosis, 46 [9.7%] developed ALT elevations above 3 times ULN; in a case control analysis, concurrent HIV infection was a risk factor).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, isoniazid was implicated in 15 cases [5%: ranking 3rd] being the only agent implicated in 13 cases and implicated with other agents in two cases; but no case was linked to ethambutol).
Kaneko Y, Nagayama N, Kawabe Y, Shimada M, Suzuki J, Kunogi M, Matsui Y, et al. (2008). Kekkaku. (Abstract: reports on substantial higher frequency of ALT elevations in patients with chronic hepatitis C associated with pyrazinamide therapy).
Tostmann A, Boeree MJ, Aarnoutse RE, de Lange WC, van der Ven AJ, Dekhuijzen R. (2008). Antituberculosis drug-induced hepatotoxicity: concise up-to-date review. J Gastroenterol Hepatol. (Review of incidence, pathogenesis, clinical course, risk factors and management of drug induced liver disease due to antituberculosis medications).
Lee JH, Park HK, Heo J, Kim TO, Kim GH, Kang DH, Song GA, et al. (2008). Drug Rash with Eosinophilia and Systemic Symptoms (DRESS) syndrome induced by celecoxib and anti-tuberculosis drugs. J Korean Med Sci. (29 year old woman developed fever, rash, eosinophilia and jaundice 6 weeks after starting celecoxib and 5 weeks after starting antituberculosis therapy with isoniazid, rifampin, pyrazinamide and ethambutol [bilirubin 3.6 mg/dL, ALT 327 U/L, Alk P 788 U/L, eosinophils 12%], improving upon stopping and recurring upon restarting with severe myositis and pneumonitis, treated with prednisone and ultimately resolved, but had positive patch tests to celecoxib and ethambutol).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 2 antituberculosis agents were among the top 40 cases, including isoniazid [24th, 47 cases] and rifampin [35th, 37 cases], but not ethambutol).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 25 to antituberculosis agents, including 15 to isoniazid alone [ranking first], 6 to isoniazid combined with other agents, 3 to rifampin and pyrazinamide and 1 to dapsone, but no cases were attributed even secondarily to ethambutol).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, 181 [58%] were attributed to antituberculosis agents which accounted for 39 of 54 [72%] fatal cases; ethambutol not specifically mentioned).
Palmero D, Castagnino J, Musella RM, Mosca C, González Montaner P, de Casado GC. (2013). Difficult clinical management of anti-tuberculosis DRESS syndrome. Int J Tuberc Lung Dis. (Analysis of 11 patients with DRESS syndrome attributed to antituberculosis medications, one was attributed to ethambutol and isoniazid and one to ethambutol with isoniazid, rifampin and pyrazinamide).
Li C, Long J, Hu X, Zhou Y. (2013). GSTM1 and GSTT1 genetic polymorphisms and risk of anti-tuberculosis drug-induced hepatotoxicity: an updated meta-analysis. Eur J Clin Microbiol Infect Dis. (Metaanalysis of studies on the association of tuberculosis drug associated liver injury and polymorphisms of the glutathione S-transferase genes found weak associations only).
Shin HJ, Lee HS, Kim YI, Lim SC, Jung JP, Ko YC, Kwon YS. (2014). Hepatotoxicity of anti-tuberculosis chemotherapy in patients with liver cirrhosis. Int J Tuberc Lung Dis. (Retrospective analysis of 197 patients treated for tuberculosis found serum enzyme elevations [72% vs 46%] and drug induced liver injury [8% vs 2.7%] more common in 50 patients who had cirrhosis than in 147 without, but all patients recovered; specific agents responsible for injury were not identified).
Kaswala DH. (2013). Drug rash with eosinophilia and systemic symptoms syndrome due to anti-TB medication. J Family Med Prim Care. (68 year old man with tuberculosis developed rash, eosinophilia and serum aminotransferase elevations [details not given] 8 weeks after starting isoniazid, rifampin, pyrazinamide and ethambutol, resolving within a month of stopping and with prednisone therapy).
Li C, Long J, Hu X, Zhou Y. (2013). GSTM1 and GSTT1 genetic polymorphisms and risk of anti-tuberculosis drug-induced hepatotoxicity: an updated meta-analysis. Eur J Clin Microbiol Infect Dis. (Metaanalysis of studies on the association of tuberculosis drug associated liver injury and polymorphisms of the glutathione S-transferase genes found weak associations only).
Kumar N, Kedarisetty CK, Kumar S, Khillan V, Sarin SK. (2014). Antitubercular therapy in patients with cirrhosis: challenges and options. World J Gastroenterol. (Review of the frequency, pathogenesis and management of hepatotoxicity of antituberculosis therapy in patients with preexisting cirrhosis, who appear to have an increased risk of liver injury from these agents as well as an increased risk of severe outcomes).
Huang YS. (2014). Recent progress in genetic variation and risk of antituberculosis drug-induced liver injury. J Chin Med Assoc. (Critical review of studies on genetic variations associated with antituberculosis drug induced liver injury focusing on N-acetyltransferase (NAT), CYP 2E1, glutathione S transferase and manganese superoxide dismutase, the strongest association being with NAT and slow acetylator status).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 13 [7%] due to antituberculosis agents including 6 to isoniazid, 1 to pyrazinamide, 1 to rifampin and 5 to combinations; ethambutol not specifically mentioned).
Jeong I, Park JS, Cho YJ, Yoon HI, Song J, Lee CT, Lee JH. (2015). Drug-induced hepatotoxicity of anti-tuberculosis drugs and their serum levels. J Korean Med Sci. (Among 195 Korean patients with tuberculosis treated with a 4-drug regimen of isoniazid, rifampin, ethambutol and pyrazinamide, drug levels taken within the first week of treatment did not correlate with subsequent rate or severity of antituberculosis drug induced liver injury [n=12: 6%]).
Horita N, Miyazawa N, Yoshiyama T, Kojima R, Ishigatsubo Y, Kaneko T. (2015). Currently used low-dose pyrazinamide does not increase liver-injury in the first two months of tuberculosis treatment. Intern Med. (Among 383 Chinese patients with tuberculosis treated with isoniazid, rifampin and ethambutol with or without pyrazinamide analyzed in a retrospective study, liver injury arising within the first two months of therapy was less frequent with four drug [8%] than 3-drug regimen [24%]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 54 [6%] were attributed to antituberculosis agents including 48 to isoniazid, 2 to rifampin, 2 to pyrazinamide, 1 to ethambutol and 1 to isoniazid and rifampin).
Sharma P, Tyagi P, Singla V, Bansal N, Kumar A, Arora A. (2015). Clinical and biochemical profile of tuberculosis in patients with liver cirrhosis. J Clin Exp Hepatol. (Among 67 patients with cirrhosis treated for tuberculosis with isoniazid, rifampin, ethambutol and either ofloxacin or pyrazinamide, evidence of drug induced liver injury arose in 35% of cases, but none were attributed to ethambutol or pyrazinamide and there were no deaths attributed to drug toxicity).
Golemba AS, Ferreyra FG, Martearena RE, Achinelli FR, Rovai GB. (2015). Drug-induced hepatotoxicity and tuberculosis in a hospital from the Argentinian northeast: cross-sectional study. Medwave. (Among 118 patients with tuberculosis treated with isoniazid, rifampin and ethambutol between 2011 and 2014, 9 (8%) developed hepatotoxicity, but only two had jaundice and none died or underwent transplantation).
Blair PW, Herrin D, Abaalkhail N, Fiser W. (2015). DRESS syndrome presenting after initiation of mycobacterium avium complex osteomyelitis treatment. BMJ Case Rep. (79 year old man developed rash, fever and eosinophilia 4 weeks after starting isoniazid, rifampin, ethambutol and clarithromycin for MAC osteomyelitis [ALT 56 rising to 86 U/L, bilirubin and Alk P not provided] which did not improve upon stopping the medications but did once high dose corticosteroids were begun; no follow up on rechallenge or outcome of osteomyelitis).
Choi JH, Heo NY, Park SH, Park CS, Jo KM, Kim WG, Nam KH. (2016). Korean J Gastroenterol. (Woman with tuberculosis developed fever, rash and eosinophilia within 2 months of starting combination therapy with isoniazid, rifampin, ethambutol and pyrazinamide [ALT rising to 650 U/L], responding to prednisone therapy and fever and rash recurring with reintroduction of ethambutol).
Usui T, Whitaker P, Meng X, Watson J, Antoine DJ, French NS, Park BK, et al. (2016). Detection of drug-responsive T-lymphocytes in a case of fatal antituberculosis drug-related liver injury. Chem Res Toxicol. (50 year old man developed liver injury 3 weeks after starting combination therapy for tuberculosis [peak bilirubin 32 mg/dL, ALT 2373 U/L, INR 4.4], dying within a month of onset; cloning of T cells taken early in the course revealed reactivity to ethambutol and rifampin but not isoniazid and pyrazinamide).
Wang FJ, Wang Y, Niu T, Lu WX, Sandford AJ, He JQ. (2016). Update meta-analysis of the CYP2E1 RsaI/PstI and DraI polymorphisms and risk of antituberculosis drug-induced hepatotoxicity: evidence from 26 studies. J Clin Pharm Ther. (Metaanalysis of 26 studies involving 7423 patients found that the CYP2E1 RsaI/PstI c1/c1 polymorphism was associated with an increased risk for liver injury caused by antituberculosis therapy with an odds ratio of 1.32).
Allouchery M, Logerot S, Cottin J, Pralong P, Villier C, Ben Saïd B. (2018). French Pharmacovigilance Centers Network and the French Investigators for skin adverse reactions to drugs. Antituberculosis drug-associated DRESS: a case series. J Allergy Clin Immunol Pract. (Among 67 cases of DRESS syndrome attributed to antituberculosis medications reported to a French pharmacovigilance registry between 2005 and 2015, there were 40 women and 27 men, median age of 61 years and the most commonly implicated agents were isoniazid and rifampin).
Tweed CD, Wills GH, Crook AM, Dawson R, Diacon AH, Louw CE, McHugh TD, et al. (2018). Liver toxicity associated with tuberculosis chemotherapy in the REMoxTB study. BMC Med. (Among 1928 patients with pulmonary tuberculosis treated with ethambutol, isoniazid, rifampin and pyrazinamide or regimens in which moxifloxacin was substituted for either ethambutol or isoniazid, liver injury arose in 58 patients [3%] overall, and was less with regimen in which moxifloxacin replaced isoniazid [2.2%], but there was nevertheless a liver related death on this regimen).
Kapur A, Rehan HS. (2019). Drug reaction with eosinophilia and systemic symptoms syndrome associated with ethambutol use: a case report. Curr Drug Saf. (34 year old woman developed fever, rash and eosinophilia 35 days after starting antituberculosis therapy with isoniazid, rifampin, pyrazinamide, ethambutol and streptomycin that responded to stopping therapy and systemic corticosteroids, but rapidly recurred upon restarting ethambutol alone and she later tolerated the other agents).
Hagiwara E, Suido Y, Asaoka M, Katano T, Okuda R, Sekine A, Kitamura H, et al. (2019). Safety of pyrazinamide-including regimen in late elderly patients with pulmonary tuberculosis: A prospective randomized open-label study. J Infect Chemother. (Among 89 elderly patients [80 years or older] with tuberculosis treated with isoniazid, rifampin and ethambutol with or without pyrazinamide, rates of discontinuation were similar between the two groups [33% vs 35%] as well as rates of ALT or AST elevations above 2.5 times ULN [18% vs 23%]).
Wang Y, Xiang X, Huang WW, Sandford AJ, Wu SQ, Zhang MM, Wang MG, et al. (2019). Association of PXR and CAR polymorphisms and antituberculosis drug-induced hepatotoxicity. Sci Rep. (Among 502 patients with tuberculosis treated with isoniazid, rifampin, ethambutol and pyrazinamide 19% developed ALT elevations above 10 times ULN, several polymorphisms of PXR [but not CAR] were associated with a lower incidence of liver injury).
Dheda K, Gumbo T, Maartens G, Dooley KE, Murray M, Furin J, Nardell EA, Warren RM. (2019). Lancet Respiratory Medicine drug-resistant tuberculosis Commission group. The Lancet Respiratory Medicine Commission: 2019 update: epidemiology, pathogenesis, transmission, diagnosis, and management of multidrug-resistant and incurable tuberculosis. Lancet Respir Med. (Review of the epidemiology, pathogenesis, diagnosis and management of multidrug resistant tuberculosis; does not discuss hepatotoxicity of therapeutic drug regimens).
Beauglehole D, Nolan D, Italiano CM. (2020). Acute liver failure likely due to ethambutol in the treatment of AIDS-associated disseminated Mycobacterium avium complex infection. Intern Med J. (34 year old man with HIV infection and Mycobacterium avium complex [MAC] infection developed cholestatic liver injury with jaundice [bilirubin ~12 mg/dL] within 4 weeks of starting isoniazid, pyrazinamide, clarithromycin, rifabutin and ethambutol and had recurrence 3 times with reinstitution of MAC therapy, eventually resolving only when switching to an ethambutol-free regimen).
Zhao H, Wang Y, Zhang T, Wang Q, Xie W. (2020). Drug-induced liver injury from anti-tuberculosis treatment: a retrospective cohort study. Med Sci Monit. (Among 140 patients with liver injury due to antituberculosis therapy seen between 2009 and 2015, the median age was 40, time to onset ranged from 7-90 days [mean=24], 35% had fever, 16% rash, 68% were hepatocellular, 21% were severe and 7% died; most patients had received isoniazid, rifampin and pyrazinamide).
Soni H, Kumar-M P, Mishra S, Bellam BL, Singh H, Mandavdhare HS, Medhi B, et al. (2020). Risk of hepatitis with various reintroduction regimens of anti-tubercular therapy: a systematic review and network meta-analysis. Expert Rev Anti Infect Ther. (Systematic review of the risk of recurrence of hepatotoxicity on reintroduction of antituberculosis agents after occurrence of drug induced liver injury indicated that sequential and incremental introduction is preferable to rechallenge with full doses of both agents concurrently).
Gezahegn LK, Argaw E, Assefa B, Geberesilassie A, Hagazi M. (2020). Magnitude, outcome, and associated factors of anti-tuberculosis drug-induced hepatitis among tuberculosis patients in a tertiary hospital in North Ethiopia: A cross-sectional study. PLoS One. (Among 188 patients treated for tuberculosis with isoniazid, rifampin, pyrazinamide and ethambutol in a single referral center in Ethiopia over a 3 year period, 26 [14%] developed evidence of drug induced liver injury including 3 who died).
CDC. https://www.cdc.gov/tb/ (CDC website with up-to-date recommendations on therapy of tuberculosis).

## OTHER REFERENCE LINKS

1 Recent References on Ethambutol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ethambutol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ethambutol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ethambutol)